# Meloxicam

## OVERVIEW

### Introduction

Meloxicam is a long acting nonsteroidal antiinflammatory drug (NSAID) available by prescription only and used in therapy of chronic arthritis. Meloxicam has been linked to rare instances of acute, clinically apparent liver injury.

### Background

Meloxicam (mel ox' i kam) belongs to the enolic or oxicam class of NSAIDs similar to piroxicam. Like other NSAIDs, the antiinflammatory and analgesic properties of meloxicam are the result of inhibition of tissue cyclooxygenases (Cox-1 and -2) which block the formation of proinflammatory prostaglandins that are important mediators of inflammatory and pain pathways. Meloxicam has a ten-fold selectivity in inhibiting Cox-2 over Cox-1 in vitro. The specificity for Cox-2 is believed to make meloxicam less likely to cause gastrointestinal mucosal injury compared to standard NSAIDs that inhibit both Cox isoenzymes, which would suggest that it should have fewer gastrointestinal side effects and less effects on platelet function than the nonselective Cox inhibitors (Cox-1 and Cox-2). However, in humans, meloxicam in full doses has a similar side effect profile as most nonselective NSAIDs, and its clinical advantage has yet to be proven. Oral meloxicam has a delayed time to onset, requiring several days to achieve its full effect, which makes it ill suited for treating acute pain, but more appropriate for chronic use as in the chronic forms of arthritis. Recently, more rapidly absorbed formulations of meloxicam have been developed that have been shown to be helpful in acute pain such as headache. Meloxicam was approved in the United States in 2000, and is currently the most frequently prescribed NSAID in the United States. Current indications vary by formulation but can include osteoarthritis, rheumatoid arthritis, and juvenile rheumatoid arthritis as well as mild-to-moderate pain including migraine and post-operative pain. Meloxicam is available by prescription only as capsules or tablets of 5, 7.5, 10, and 15 mg in generic forms and under several brand names including Mobic and Vivlodex. The recommended dose in chronic arthritic conditions is 7.5 to 15 mg by mouth once daily. Fixed dose combinations with other agents are available for therapy of migraine (Zymbravo: meloxicam with rizatriptan) and postsurgical analgesia (Zynrelef: meloxicam with bupivacaine). It is also available as an oral suspension of 7.5 mg/5 mL for use in children and as a solution for intravenous administration (Xifyrm: 30 mg once daily) for moderate-to-severe pain. Because of its efficacy and once-a-day dose, meloxicam has become the most commonly prescribed NSAID, with more than 20 million prescriptions filled yearly in the United States. Like most NSAIDs, meloxicam is generally well tolerated, but side effects can include gastrointestinal upset and pain, nausea, headache, dizziness, somnolence, itching, peripheral edema and hypersensitivity reactions. As with other NSAIDS, meloxicam has potential serious adverse effects, including severe gastrointestinal complications [such as ulcers, bleeding, or perforation], increase risk of cardiovascular thrombotic events [such as myocardial infarction or stoke], renal dysfunction, heart failure and edema, exacerbation of asthma, infertility, fetal toxicity, and hypersensitivity reactions.

### Hepatotoxicity

In prospective studies, up to 7% of patients taking meloxicam experienced at least transient serum aminotransferase elevations. These were usually mild and resolved even while continuing the drug and without dose modification. Aminotransferase elevations above 3 times the upper limit of normal (ULN) occurred in 1% of patients. Clinically apparent liver injury with jaundice from meloxicam is rare and only individual case reports have been published. The latency to onset in reported cases was short (1 to 5 weeks) and both cholestatic and hepatocellular patterns of enzyme elevations were described. Immunoallergic features were usually not prominent and autoantibodies were rare, although a single case report of autoimmune hepatitis apparently triggered by meloxicam therapy has been published. Recovery is typically rapid once meloxicam is stopped. Meloxicam is rarely mentioned as an etiologic agent in large case series on drug induced liver injury and acute liver failure. While at least a dozen cases of meloxicam induced liver injury have been published, it is a commonly prescribed NSAID, and the incidence of hepatotoxicity with its use is probably less than 1 in 50,000 persons.

Likelihood score: B (likely rare cause of clinical apparent liver injury).

### Mechanism of Injury

The mechanism of meloxicam hepatotoxicity is not known. It is metabolized in the liver, largely by CYP 2C9 and to a lesser extent by CYP 3A4, and liver injury may be due to production of a toxic or immunogenic metabolite.

### Outcome and Management

The severity of liver injury from meloxicam ranges from asymptomatic elevations in serum aminotransferase levels, to symptomatic hepatitis with or without jaundice. Fatal and chronic cases have not been described. Although cross sensitivity has not been shown, patients with clinically apparent meloxicam induced liver injury should probably avoid other oxicam NSAIDs such as piroxicam.

Drug Class: Nonsteroidal Antiinflammatory Drugs, see also Piroxicam

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Meloxicam – Generic, Mobic®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Meloxicam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Meloxicam | 71125-38-7 | C14-H13-N3-O4-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2025

Abbreviations used: NSAID, nonsteroidal antiinflammatory drug.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Review of hepatotoxicity of NSAIDs published in 1999; meloxicam is not discussed).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Textbook of hepatotoxicity published in 2013 mentions that meloxicam had yet to be associated with hepatic abnormalities).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain and gout. In, Brunton LL, Hilal Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Review of liver injury due to NSAIDs; meloxicam is not mentioned). 2281340
Distel M, Mueller C, Bluhmki E, Fries J. Safety of meloxicam: a global analysis of clinical trials. Br J Rheumatol 1996; 35 (Suppl 1): 68-77. (Analysis of safety of 7.5 and 15 mg of meloxicam among 4175 patients in controlled trials in rheumatoid arthritis and osteoarthritis; ALT or AST elevations occurred in 5.9% at 7.5 mg, 7.4% at 15 mg, vs 6.3% with piroxicam, 16.1% with diclofenac and 9.5% with naproxen). 8630641
Furst DE. Meloxicam: selective COX-2 inhibition in clinical practice. Semin Arthritis Rheum 1997; 26: 21-7. (Safety analysis in over 4000 patients on meloxicam; fewer gastrointestinal complaints with meloxicam; similar data as in Distel [1996]: ALT levels >2 times ULN occurred in 2% of meloxicam vs 5% of diclofenac recipients; no mention of hepatitis or jaundice). 9219316
Staerkel P, Horsmans Y. Meloxicam-induced liver toxicity. Acta Gatroenterol Belg 1999; 62: 255-6. (46 year old woman with rheumatoid arthritis developed anorexia 4 days after starting meloxicam, and despite stopping developed fatigue and jaundice 8 days later [bilirubin 10.4 mg/dL, ALT 2340 U/L, Alk P 520 U/L], resolving within 1 month of stopping; was ANA positive, but without rash, fever or eosinophilia: patient had tolerated piroxicam without difficulty). 10427794
Martin RM, Biswas P, Mann RD. The incidence of adverse events and risk factors for upper gastrointestinal disorders associated with meloxicam use amongst 19,087 patients in general practice in England: cohort study. Br J Clin Pharmacol 2000; 50: 35-42. (Among 19,087 users of meloxicam common side effects were dyspepsia, abdominal pain, nausea, headache and rash; but only one patient had “idiosyncratic liver abnormalities”, but details not given). 10886116
Gierer IM, Abdala O, Calderón C, Risoli E, Cravero A, Pinchuk L. [Meloxican-induced cholestasis] Acta Gastroenterol Latinoam 2000; 30: 511-4. Spanish. PMID: 11144948 (75 year old woman developed pruritus after 2 weeks and jaundice after 5 weeks of meloxicam therapy and at 7 weeks had bilirubin 25 mg/dL, ALT 40 U/L, Alk P 559 U/L, biopsy showing intrahepatic cholestasis with slow, but complete resolution by 4 months).
Yocum D, Fleischmann R, Dalgin P, Caldwell J, Hall D, Roszko P, Meloxicam Osteoarthritis Investigators. Safety and efficacy of meloxicam in the treatment of osteoarthritis. A 12-week, double-blind, multiple-dose, placebo-controlled trial. Arch Intern Med 2000; 160: 2947-54. (Among 774 patients enrolled at 61 centers in an industry supported randomized controlled trial of 3 doses of meloxicam vs placebo or diclofenac for 12 weeks, side effects were less with meloxicam than with diclofenac, but more than with placebo; no mention of ALT elevations or liver injury). 11041902
Furst DE, Kolba KS, Fleischmann R, Silverfield J, Greenwald M, Roth S, et al. Meloxicam Rheumatoid Arthritis Investigators. Dose response and safety study of meloxicam up to 22.5 mg daily in rheumatoid arthritis: a 12 week multicenter, double blind, dose response study versus placebo and diclofenac. J Rheumatol 2002; 29: 436-46. (Among 894 patients with rheumatoid arthritis enrolled in an industry supported randomized clinical trial of 3 doses of meloxicam vs placebo or diclofenac for 12 weeks, ALT elevations were less common with meloxicam [6.9-8.9%] than with placebo [12.2%] and much less than with diclofenac [30%]). 11908554
Fleischmann R, Iqbal I, Stobodin G. Meloxicam. Expert Opin Pharamcother 2002; 3: 1501-12. (Overview of this Cox-2 preferential NSAID showing similar therapeutic activity to piroxicam and diclofenac with less gastrointestinal side effects; elevated liver enzymes reported in <2% of patients; no mention of hepatitis or jaundice). 12387696
Traversa G, Bianchi C, Da Cas R, Abraha I, Menniti-Ippolito F, Venegoni M. Cohort study of hepatotoxicity associated with nimesulide and other non-steroidal anti-inflammatory drugs. BMJ 2003; 327: 18-22. (Among 397,537 patients who received a prescription for an NSAID [770,000 person years] between 1997 and 2002, 42 developed an acute nonviral hepatitis including 1 of 4232 receiving meloxicam). 12842950
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie(CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France found 88 cases and identified 178 controls; 22 cases vs 16 controls were exposed to NSAIDs; 5 diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen, and 1 meloxicam, rest to salicylates which was used as frequently in controls; no fatalities). 15066135
Rostom A, Goldkind L, Laine L. Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol 2005; 3: 489-98. (Review of randomized clinical trials of NSAIDS for frequency of adverse events; ALT >3 times ULN occurred in 0.43% of ibuprofen, 0.43% naproxen, 0.42% celecoxib, 1.8% rofecoxib, 3.55% diclofenac, and 0.29% of placebo recipients; among 10,048 patients in five publications on meloxicam, rate was 0.19% and thus less than reported with placebo). 15880319
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, 3 attributed to naproxen, but none to meloxicam). 16165719
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20:391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; among more than 29,000 liver adverse event reports, 26 were for meloxicam; no clinical details given). 16867024
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verma A, et al. Use of cyclo-oxygenase 2 inhibitors (COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. (Survey of NSAID use in UK and USA indicates meloxicam is among the top 10 NSAIDs used). 17086563
Sanchez-Matienzo D, Arana A, Castellsague J, Perez-Gutthann S. Hepatic disorders in patients treated with COX-2 selective inhibitors or nonselective NSAIDs: a case/noncase analysis of spontaneous reports. Clin Ther 2006; 28: 1123-32. (Among more than 300,000 spontaneous reports of adverse events due to NSAIDs, 3% being hepatic; the proportion of adverse events that were hepatic was highest for bromfenac [20.7%] and nimesulide [14.4%], but was also elevated for sulindac [9.9%], diclofenac [4.7%], and less so for meloxicam [3.8%]). 16982289
Raber A, Heras J, Costa J, Fortea J, Cobos A. Incidence of spontaneous notifications of adverse reactions with aceclofenac, meloxicam, and rofecoxib during the first year after marketing in the United Kingdom. Ther Clin Risk Management 2007; 3: 225-230. (Summary analysis of spontaneous reports to WHO in first year of meloxicam use suggested liver toxicity was highest with rofecoxib [0.775], intermediate with aceclofenac [0.241], and lowest with meloxicam [0.097 per million drug doses]). 18360631
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. PubMed Citation (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam, and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]). 18955056
Suzuki R, Yamamoto M, Saka H, Taniguchi H, Shindoh J, Tanikawa Y, et al. A phase II study of carboplatin and paclitacel with meloxicam. Lung Cancer 2009; 63: 72-6. (44 patients with lung cancer given carboplatin and paclitacel with meloxicam; 3 developed elevations in ALT, all were mild and resolved; no details given and difficult to attribute to meloxicam vs cancer chemotherapy). 18499296
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; meloxicam is not discussed). 21128314
Martínez-Odriozola P, Gutiérrez-Macías A, Ibarmia-Lahuerta J, Muñóz-Sánchez J. Meloxicam as a cause of drug-induced autoimmune hepatitis. Dig Dis Sci 2010; 55: 1191-2. (64 year old man developed fatigue followed by jaundice 5 to 6 weeks after starting meloxicam with worsening despite stopping meloxicam [bilirubin 2.9 rising to 8.2 mg/dL, AST 768 to 1591 U/L, Alk P 129 to 155 U/L, ANA positive, high globulins], improving with corticosteroid therapy, but still on treatment 6 months later with persistence of mild enzyme elevations [AST 85 U/L]). 19399620
Suzuki A, Andrade RJ, Bjornsson E, Lucena MI, Lee WM, Yuen NA, Hunt CM, et al. Drugs associated with hepatotoxicity and their reporting frequency of liver adverse events in VigiBase: unified list based on international collaborative work. Drug Saf 2010; 33: 503-22. (Combined analysis of 3 large databases on drug induced liver injury from Spain, Sweden and the US; among the 65 agents linked to at least 5 cases, diclofenac [n=38], ibuprofen [28], naproxen [14], nimesulide [9], and piroxicam [5] are listed, but not meloxicam). 20486732
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac, and 1 to etodolac, but none to meloxicam). 20949552
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of 42,389 spontaneous serious adverse event reports to the French Pharmacovigilance database on 8 NSAIDs between 2002 and 2006; liver adverse events were most frequent with nimesulide [0.15 per million daily doses] compared to diclofenac [0.09], ketoprofen [0.09] piroxicam [0.06], naproxen [0.04], meloxicam [0.03], and tenoxicam [0.03]). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (Population based prospective analysis of cases of drug induced liver injury seen over a two year period in Iceland identified 96 cases, 6 of which were due to NSAIDS, all 6 attributed to diclofenac, but none were attributed to meloxicam or other NSAIDs). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996-2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], but specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; meloxicam was not listed]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. PMID: 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs, 3 of which were attributed to meloxicam all of which were symptomatic and jaundiced but none of which were fatal [Schmeltzer 2016]).
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, including 3 to meloxicam, all with a short latency [<1 month], cholestatic or mixed enzyme elevations, moderate severity and ultimately full resolution). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010-2014, NSAIDs that were used more frequently in cases than controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59], and risk was higher in those taking higher doses; meloxicam was not mentioned). 26991794
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of Nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol 2018; 2018: 5253623. (A systematic review of published randomized controlled trials of NSAIDs for evidence of hepatotoxicity found only 18 studies that fit the stringent criteria including 11 for diclofenac, 5 for naproxen, but none for meloxicam). 29568654
Bergese SD, Melson TI, Candiotti KA, Ayad SS, Mack RJ, McCallum SW, Du W, et al. A phase 3, randomized, placebo-controlled evaluation of the safety of intravenous meloxicam following major surgery. Clin Pharmacol Drug Dev 2019; 8: 1062-72. (Among 721 patients who were treated with once daily intravenous meloxicam [30 mg] or placebo for 1-7 days after undergoing major surgery, adverse event rates were similar in the two groups including ALT elevations [2% vs 3.8%] and those above 3 times ULN [2.0% vs 2.4%], and there were no serious hepatic events). 30786162
Nguyen KD, Tran TN, Nguyen MT, Nguyen HA, Nguyen HA Jr, Vu DH, Nguyen VD, et al. Drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Vietnamese spontaneous adverse drug reaction database: a subgroup approach to disproportionality analysis. J Clin Pharm Ther; 44: 69-77. (Among 136 cases of Stevens Johnson Syndrome or Toxic Epidermal Necrolysis reported to a Vietnamese national adverse event registry between 2010-2015, the major causes were carbamazepine [n=25], acetaminophen [22], allopurinol [15], cephalosporins [15], HDS [7], SMZ/TMP [6], rifampicin [5], ethambutol [4], streptomycin [4], colchicine [4], valproate [3], and meloxicam [3]). 30129156
Rechberger T, Mack RJ, McCallum SW, Du W, Freyer A. Analgesic efficacy and safety of intravenous meloxicam in subjects with moderate-to-severe pain after open abdominal hysterectomy: a phase 2 randomized clinical trial. Anesth Analg. 2019;128:1309-1318.. (Among 486 women undergoing open elective hysterectomy who were treated on post-operative day 1 with a single infusion of intravenous meloxicam [5, 7.5, 15, 30 or 60 mg], morphine [0.15 mg/kg] or placebo, pain relief was similar with meloxicam and morphine and superior to placebo, there were no treatment related serious adverse events and transient serum enzyme abnormalities arose in 5 [1%] meloxicam vs 2 [0.4%] placebo recipients). 31094806
Sharpe KP, Berkowitz R, Tyndall WA, Boyer D, McCallum SW, Mack RJ, Du W. Safety, tolerability, and effect on opioid use of meloxicam iv following orthopedic surgery. J Pain Res. 2020 Jan 21;13:221-229.. (Among 379 patients undergoing orthopedic surgery treated with intravenous meloxicam or placebo post-operatively for up to 7 days, adverse event rates were similar in the two groups [65% vs 69%] as were “hepatic” events [9.5% vs 7.3%]). 32021411
IV meloxicam (Anjeso) for pain. Med Lett Drugs Ther. 2020;62(1601):100-102.. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of intravenous meloxicam for pain shortly after its approval for use in the United States, mentions adverse effects of constipation, GGT elevations, and anemia but overall rates of adverse events were similar to those in placebo groups; states hepatotoxicity occurs rarely with NSAID therapy). 32724022
Silinsky JD, Marcet JE, Anupindi VR, Karkare SU, Shah DR, Mack RJ, McCallum SW, et al. Preoperative intravenous meloxicam for moderate-to-severe pain in the immediate post-operative period: a Phase IIIb randomized clinical trial in 55 patients undergoing primary open or laparoscopic colorectal surgery with bowel resection and/or anastomosis. Pain Manag. 2021;11:9-21.. (Among 55 adults undergoing colorectal surgery who were treated for moderate-to-severe pain postoperatively with either intravenous meloxicam or placebo, both pain and opiate use was less with meloxicam, adverse event rates were similar in the two groups, and there were no differences in clinical laboratory findings). 33094682
Berkowitz RD, Mack RJ, McCallum SW. Meloxicam for intravenous use: review of its clinical efficacy and safety for management of postoperative pain. Pain Manag. 2021;11:249-258.. (In multiple phase II and III controlled trials of intravenous meloxicam given pre- and post-operatively of various forms of surgery, meloxicam was consistently more effective than placebo for pain relief and similar to intravenous ketorolac, while adverse event rates, including ALT elevations [2% vs 4%] and “hepatic events” [6.5% vs 8.2%] were similar with meloxicam as with placebo or an active control). 33291975
Hu F, Wu G, Zhao Q, Wu J. Evaluation of analgesic effect, joint function recovery and safety of meloxicam in knee osteoarthritis patients who receive total knee arthroplasty: a randomized, controlled, double-blind study. Medicine (Baltimore). 2021;100:e26873.. (Among 128 Chinese adults undergoing total knee arthroplasty for osteoarthritis who were treated with either oral meloxicam or placebo 4 to 72 hours post-operatively, pain relief was better with meloxicam and rates of adverse events [nausea, constipation, dizziness) were similar between the two groups; no mention of ALT levels). 34477120
Yuan H, Curran JG, Keith SW, Hopkins MM, Silberstein SD. Intravenous ibuprofen for acute treatment of migraine: A double-blind, randomized, placebo-controlled pilot study. Headache. 2021;61:1432-1440.. (Among 74 patients with acute migraine treated with either intravenous ibuprofen or placebo within 2 to 72 hours of onset, pain relief was attained within 2 hours in 74% vs 48%, and adverse event rates were similar [17% vs 14%], and no serious adverse events occurred). 34601736
Bupivacaine/meloxicam (Zynrelef) for postsurgical pain. Med Lett Drugs Ther. 2022;64(1642):13-15.. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of the combination of bupivacaine and meloxicam as an extended release solution for single dose intraoperative parenteral instillation, mentions that the combination provided better post-operative pain relief and that side effects were largely constipation, nausea, and headache but also mentions that systemic NSAIDs can cause ALT and AST elevations). 35134044
Haffar A, Fillingham YA, Breckenridge L, Gursay D, Lonner JH. Meloxicam versus celecoxib for postoperative analgesia after total knee arthroplasty: safety, efficacy and cost. J Am Acad Orthop Surg Glob Res Rev. 2022;6:e22.00032. PMID: 35389917. (In a retrospective analysis of 4994 patients who underwent total knee arthroplasty between 2015 and 2020 treated post-operatively with either meloxicam [7.5 or 5 mg] or celecoxib once daily, there were no differences in rates of complications including gastrointestinal bleeding, thromboses, wound complications, and renal injury; no mention of ALT levels or hepatotoxicity).
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 4 were attributed to meloxicam including 3 women and 1 man, median age 65.7 years, latency 23 days, initial bilirubin 5.9 mg/dL, ALT 241 U/L, and Alk P 366 U/L). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib; meloxicam was not mentioned). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 23 cases due to diclofenac for an estimated incidence of 1 per 4,800 new persons treated each year, while other NSAIDs had lower numbers and estimated rates, including celecoxib [4, 1:25,000] and meloxicam [n=3, 1:87,000], incidence rates for ibuprofen and naproxen could not be estimated because of lack of data on over-the-counter use). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen, and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam [personal communication]). 38992407
A fixed-dose combination of meloxicam and rizatriptan (Symbravo) for migraine. Med Lett Drugs Ther. 2025;67(1727):68-70. PMID:. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of the combination of meloxicam and rizatriptan as therapy for migraine shortly after its approval for use in the United States does not mention ALT elevations or hepatotoxicity). 40261316

## OTHER REFERENCE LINKS

1. Recent References on Meloxicam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(meloxicam/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Meloxicam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=meloxicam)